# Aztreonam

## OVERVIEW

### Introduction

Aztreonam is a parenterally administered, synthetic monobactam antibiotic that is specifically active against aerobic gram-negative bacilli is resistant to many beta-lactamases. Aztreonam therapy is often accompanied by mild, asymptomatic elevations in serum aminotransferase levels, but it has not been reported to cause clinically apparent liver injury.

### Background

Aztreonam (az tree' oh nam) is a monocyclic beta-lactam compound (monobactam) that was originally isolated from Chromobacterium violaceum. It acts by binding to penicillin binding proteins inhibiting cell wall synthesis and decreasing bacterial growth. Aztreonam is active mostly against gram negative organisms and more closely resembles aminoglycosides rather than penicillins. Aztreonam was approved for use in the United States in 1986 and is indicated in the treatment of various moderate-to-severe systemic or skin, intra-abdominal, genitourinary, and respiratory gram-negative infections. Aztreonam is available in generic forms and under the brand name Azactam as a powder or a solution for injection, and under the brand name Cayston as a powder for solution to use in inhalational therapy. The recommended dosage is 0.5 to 2 g by intravenous or intramuscular injection every 8 to 12 hours, typically for 5 to 14 days. The most common side effects of aztreonam are injection site phlebitis, rash and gastrointestinal symptoms.

### Hepatotoxicity

Aztreonam has systemic toxicities that are similar to those of other beta lactam antibiotics, but it is unclear whether it can cause hepatic injury similar to that of the penicillins or cephalosporins. Asymptomatic serum aminotransferase elevations are common during high dose, intravenous aztreonam therapy (10% to 38%). The enzyme abnormalities are usually mild-to-moderate, asymptomatic, self-limited and not requiring drug discontinuation. Enzyme elevations occur slightly more commonly during aztreonam therapy than with other comparative antibiotics. Cases of frank liver injury and jaundice attributable to aztreonam must be extremely rare as no individual cases have been reported. For this reason, there is no data regarding the latency or pattern of the injury. Instances of marked aminotransferase elevations within 3 to 5 days of starting aztreonam have been reported, but these cases were without jaundice and resolved rapidly once the drug was stopped.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of injury

Aztreonam has little hepatic metabolism and is excreted rapidly and largely unchanged in the urine, perhaps explaining the lack of hepatotoxicity associated with its use.

### Outcome and Management

In the majority of cases, aztreonam induced liver injury appears to be transient, mild and asymptomatic, being marked by serum enzyme elevations only. Full recovery is expected after stopping the medication.

Drug Class: Antiinfective Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Aztreonam – Azactam®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=aztreonam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Aztreonam | 78110-38-0 | C13-H17-N5-O8-S2 | Aztreonam chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 02 August 2017

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-637. (Expert review of liver injury due to antimicrobial agents published in 1999; aztreonam is not discussed).
Moseley RH. Other beta-lactam antibiotics. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 466. (Expert review of antibiotic induced liver injury mentions that aztreonam and the carbapenems are associated with a high rate of serum enzyme elevations, but have not been convincingly linked to cases of clinically apparent liver injury).
Petri WA Jr. Penicillins, cephalosporins, and other betalactam antibiotics. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1477-504. (Textbook of pharmacology and therapeutics).
Swabb EA, Leitz MA, Pilkiewicz FG, Sugerman AA. Pharmacokinetics of the monobactam SQ 26,776 after single intravenous doses in healthy subjects. J Antimicrob Chemother 1981; 8 (Suppl E): 131-40. (Controlled pharmacokinetic study in 48 patients; one patient who received aztreonam developed self-limited, asymptomatic elevations in ALT and AST at 72 hours). 7199041
Miller LK, Sanchez PL, Berg SW, Kerbs SB, Harrison WO. Effectiveness of aztreonam, a new monobactam antibiotic, against penicillin-resistant gonococci. J Infect Dis 1983; 148: 612. (Controlled trial of aztreonam vs spectinomycin in 93 men with gonococcal urethritis; both agents were 100% effective and there were no side effects except for 1 patient with minimally elevatied AST, but normal ALT levels). 6225808
Swabb EA, Sugerman AA. Review of single- and multiple-dose pharmacokinetics of the monobactam, aztreonam (SQ 26,776) in healthy subjects. Chemotherapy 1983; 29: 313-21. (Among 90 patients receiving aztreonam, 8% developed ALT or AST elevations). 6684541
Greenberg RN, Reilly PM, Luppen KL, McMillian R, Bollinger M, Wolk SM, Darji TB. Treatment of serious gram-negative infections with aztreonam. J Infect Dis 1984; 150: 623-30. (Aztreonam given to 106 seriously ill patients for 5-50 days; 36% had elevations of AST, all less than 3 times ULN). 6541672
Sattler FR, Moyer JE, Schramm M, Lombard JS, Appelbaum PC. Aztreonam compared with gentamicin for treatment of serious urinary tract infections. Lancet 1984; 1: 1315-8. (In a controlled trial of aztreonam vs gentamicin in 35 patients, asymptomatic elevations in ALT [3-5 times ULN] elevations occurred in 20% of aztreonam vs 11% of gentamicin recipients). 6145024
Hauben M, Adler C. Acute hepatitis, interstitial nephritis, and eosinophilia. Ann Intern Med 1995; 122: 555-6. (A patient with HIV developed acute rise in ALT [from 47 to 2374 U/L] and creatinine [from 0.8 to 7.6 mg/dL] and eosinophilia with no mention of jaundice within 4 days of starting vancomycin and aztreonam; values improved after stopping, but were still abnormal 7 days later; patient also received a day of erythromycin). 7872595
Hara K, Kobayashi H, Nishiura T, Yura J, Saito A. Clinical studies of aztreonam in Japan. Rev Infect Dis 1985; 7 (Suppl 4): S810-24. (In studies at 86 institutions among 1,447 patients in Japan, aztreonam was effective in 67% of patients; ALT elevations occurred in 4% of patients, but were self-limited and mild in all, and no patient had associated clinical symptoms).3909341
Newman TJ, Dreslinski GR, Tadros SS. Safety profile of aztreonam in clinical trials. Rev Infect Dis 1985; 7 (Suppl 4): S648-55. (Summary of safety and efficacy trials of aztreonam; among 2388 patients receiving multiple doses, 2-3% developed ALT or AST elevations of more than 3 times ULN, but no patient developed ALT elevations and jaundice). 2934785
Bosso JA, Black PG, Matsen JM. Efficacy of aztreonam in pulmonary exacerbations of cystic fibrosis. Pediatr Infect Dis J 1987; 6: 393-7. (In open label study of aztreonam in 25 patients with cystic fibrosis, ALT elevations occurred in 16, but were always asymptomatic and resolved with stopping therapy).3588112
Bosso JA, Black PG. Controlled trial of aztreonam vs. tobramycin and azlocillin for acute pulmonary exacerbations of cystic fibrosis. Pediatr Infect Dis J 1988; 7: 171-6. (In controlled trial of aztreonam vs tobramycin and azlocillin in 30 children with an acute pulmonary exacerbation of cystic fibrosis, ALT elevations were more common with aztreonam).3128767
DeMaria A Jr, Treadwell TL, Saunders CA, Porat R, McCabe WR. Randomized clinical trial of aztreonam and aminoglycoside antibiotics in the treatment of serious infections caused by gram-negative bacilli. Antimicrob Agents Chemother 1989; 33: 1137-43. (Among 63 patients treated with aztreonam, 17% had ALT elevations of 2 to 3 fold, one with symptoms, all resolving with stopping therapy).2679368
Matsen JM, Bosso JA. The use of aztreonam in the cystic fibrosis patient. Pediatr Infect Dis J 1989; 8 (9 Suppl): S117-9; discussion S128-32. (Review of trials of aztreonam [Bosso et al 1987 and 1988] in patients with cystic fibrosis; frequent elevations in ALT levels were most common adverse event and were always asymptomatic and self-limited).2682510
Sion ML, Pyrpasopoulos M, Nicolaidis P, Papagianni C, Tsurutsoglu G. Efficacy and safety of aztreonam in the treatment of patients with renal failure. Rev Infect Dis 1991; 13 (Suppl 7): S652-4. (In open label study of aztreonam in 39 patients with renal failure and bacterial infection, ALT elevations occurred in 4 patients [10%], but were invariably mild, asymptomatic and resolved rapidly with stopping therapy).2068477
Oermann CM, Retsch-Bogart GZ, Quittner AL, Gibson RL, McCoy KS, Montgomery AB, Cooper PJ. An 18-month study of the safety and efficacy of repeated courses of inhaled aztreonam lysine in cystic fibrosis. Pediatr Pulmonol 2010; 45: 1121-34. (Among 274 children and adults with cystic fibrosis treated with inhaled aztreonam 2 or 3 times daily for up to 18 months, most adverse events were attributed to the underlying disease and "clinically significant changes in vital signs or mean clinical laboratory values were not observed"). 20672296
Corey GR, Wilcox M, Talbot GH, Friedland HD, Baculik T, Witherell GW, Critchley I, et al. Integrated analysis of CANVAS 1 and 2: phase 3, multicenter, randomized, double-blind studies to evaluate the safety and efficacy of ceftaroline versus vancomycin plus aztreonam in complicated skin and skin-structure infection. Clin Infect Dis 2010; 51: 641-50. (Among 1378 patients with complicated skin or soft tissue infections treated with ceftaroline or vancomycin with aztreonam, clinical cure rates were similar as were total and serious adverse event rates overall, ALT or elevations occurring in 2.2% vs 3.6%). 20695801
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which was attributed to aztreonam). 20949552
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, but none were attributed to aztreonam). 22379337
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period none of which were attributed to aztreonam). 23419359
Hutchinson D, Barclay M, Prescott WA, Brown J. Inhaled aztreonam lysine: an evidence-based review. Expert Opin Pharmacother 2013; 14: 2115-24. (Review of the pharmacology, efficacy and safety of aztreonam lysine used as inhalation therapy in patients with cystic fibrosis; mentions that adverse events are mostly attributable to the underlying lung disease; no mention of ALT elevations or hepatotoxicity). 3992352
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to aztreonam). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 cases [36%] were attributed to antibiotics, but none to aztreonam). 25754159
Dryden M, Zhang Y, Wilson D, Iaconis JP, Gonzalez J. A Phase III, randomized, controlled, non-inferiority trial of ceftaroline fosamil 600 mg every 8 h versus vancomycin plus aztreonam in patients with complicated skin and soft tissue infection with systemic inflammatory response or underlying comorbidities. J Antimicrob Chemother 2016; 71: 3575-84. (Among 761 patients with severe skin and soft tissue infections treated with either ceftaroline or vancomycin and aztreonam, clinical cure rates were similar as were most adverse event rates, serum enzyme elevations arising in 0.8% vs 2.7%, but there were no serious hepatic-related adverse events in the vancomycin-aztreonam group). 27585969
Korczowski B, Antadze T, Giorgobiani M, Stryjewski ME, Jandourek A, Smith A, O'Neal T, et al. A multicenter, randomized, observer-blinded, active-controlled study to evaluate the safety and efficacy of ceftaroline versus comparator in pediatric patients with acute bacterial skin and skin structure infection. Pediatr Infect Dis J 2016; 35: e239-47. (Among 159 children with acute bacterial skin and skin structure infections treated with intravenous ceftaroline or comparator antibiotics, clinical cure rates were similar as were adverse events including clinical chemistry abnormalities; ALT elevations above 3 times ULN occurred in 1% on ceftaroline and 2% on comparator agents [1 patient in each group]). 27164462

## OTHER REFERENCE LINKS

1. Recent References on Aztreonam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=aztreonam/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221985%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Aztreonam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=aztreonam)